# Erythropoiesis Stimulating Agents

## OVERVIEW

### Introduction

Epoetin is a recombinant form of erythropoietin, a hematologic growth factor that induces proliferation and maturation of red blood cells and is used in the treatment of anemia caused by renal disease, myelodysplasia, cancer chemotherapy and hematopoietic cell transplantation. Epoetin and its various derivatives have not been associated with serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Epoetin (e poe' e tin) is a recombinant form of erythropoietin, a 165 amino acid glycoprotein that induces red blood cell production from their progenitors in the bone marrow. Erythropoietin is normally made in the kidneys and acts on progenitor erythroblasts through the erythropoietin receptor to cause proliferation and maturation of red cells. The major stimulus to erythropoietin synthesis is tissue hypoxia, but other factors can modulate the response. Deficiency of erythropoietin synthesis is common in end stage renal disease and may also be present in premature infants and in patients with malignancies, chronic inflammation and cancer chemotherapy. Recombinant forms of erythropoietin became available in the 1980’s and were shown to raise hemoglobin and hematocrit levels in patients with end stage renal disease on hemodialysis, as well as in patients receiving cancer chemotherapy and patients with AIDS on drugs that cause anemia. Epoetin alfa was approved for use to treat anemia in patients with renal disease and receiving cancer chemotherapy in 1989 and is now widely used. Indications have broadened to include reduction of allogeneic red cell transfusion in patients undergoing elective surgery and it is used off-label for other forms of anemia associated with relative erythropoietin deficiency. The target hemoglobin level is usually between 11 and 12 g/dL. Epoetin alfa is available as a liquid solution for subcutaneous administration in vials and prefilled syringes under the brands name Epogen and Procrit, the dose and regimen varying by indication and initial response, being given by subcutaneous or intravenous injection at intervals varying from daily, several times weekly, weekly or as needed to achieve a target hemoglobin. Longer acting formulations are also available including darbepoetin (Aranesp: 2001) and peginesatide (Omontys, 2012, now withdrawn). Darbepoetin alfa (dar” be poe’ e tin) is a modified (hyperglycosylated) recombinant erythropoietin that has an extended half-life and can be administered every one to three weeks. Darbepoetin is available in single dose vials and prefilled syringes of varying concentrations and is administered intravenously or subcutaneously. Peginesatide (peg” in es’ a tide) is a novel synthetic pegylated dipeptide that mimics the effects of erythropoietin on red cell progenitors, despite having no amino acid homology to the native growth factor. Peginesatide was typically given either subcutaneously or intravenously at 4 week intervals, but was withdrawn from the market in 2013 because of reports of severe hypersensitivity reactions. Epoetin, darbepoetin and peginesatide are collectively referred to as erythropoiesis-stimulating agents (ESA). Dosages and dose regimens (daily, three times weekly, weekly, and every two to four weeks) vary by formulation, indications and initial response. Common side effects include hypertension (particularly in patients with renal disease), muscle and joint aches, fever, dizziness, headache, depression, cough and injection site reactions. Potentially serious, but rare side effects include hypersensitivity reactions, vascular occlusions, stroke and myocardial infarction.

### Hepatotoxicity

Epoetin and the erythropoiesis-stimulating agents have not been linked to instances of significant serum enzyme elevations or clinically apparent liver injury. In multiple large prelicensure studies, acute liver injury was not mentioned as an adverse event and serum enzyme tests changed minimally, if at all. Since licensure and wide scale use, there have been no published reports of liver injury from epoetin or its long acting forms. Interestingly, instances of induction of attacks of acute porphyria have been reported after epoetin use, probably because of induction hemoglobin production which requires an increase in porphyrin synthesis.

Likelihood score (all ESAs): E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

A mechanism of injury that might lead to serum enzyme elevations during therapy with the ESAs is not known. Epoetin is a non-glycosylated form of erythropoietin and appears to be metabolized at multiple sites, probably by the cells on which they act.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) during ESA therapy should lead to dose reduction or temporary cessation. Epoetin and its derivatives have not been implicated in cases of severe hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no reason to suspect any degree of cross sensitivity in risk for hepatic injury among the various hematologic growth factors and other agents used to treat bone marrow insufficiency.

Drug Class: Hematologic Growth Factors

Other Erythropoiesis Stimulating Agents: Daprodustat

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Epoetin – Epogen®, Procrit®

Darbepoetin – Aranesp®

Peginesatide – Omontys®

DRUG CLASS

Hematologic Growth Factors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Erythropoiesis%20Stimulating%20Agents)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Epoetin | 113427-24-0 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 05 December 2017

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp 555-88. (Review of hepatotoxicity published in 1999; the hematologic growth factors are not specifically mentioned).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; hematologic growth factors are not discussed).
Kaushansky K, Kipps TJ. Hematopoietic agents: growth factors, minerals and vitamins. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1067-99. (Textbook of pharmacology and therapeutics).
Lim VS, DeGowin RL, Zavala D, Kirchner PT, Abels R, Perry P, Fangman J. Recombinant human erythropoietin treatment in pre-dialysis patients. A double-blind placebo-controlled trial. Ann Intern Med 1989; 110: 108-14. (Controlled trial of 3 doses of epoetin vs placebo given intravenously 3 times weekly for 8 weeks in 14 patients with renal disease and anemia showed dose related increases in hematocrit and no adverse events: “liver function tests …were normal and did not change”). 2909202
Sundal E, Kaeser U. Correction of anaemia of chronic renal failure with recombinant human erythropoietin: safety and efficacy of one year's treatment in a European multicentre study of 150 haemodialysis-dependent patients. Nephrol Dial Transplant 1989; 4: 979-87. (Among 150 patients with anemia and ESRD on hemodialysis treated with epoetin for one year, almost all achieved an increase in hemoglobin to target levels; side effects included increase in blood pressure, hypertensive episodes, myocardial infarction, seizures [n=4] and thrombosis; no mention of ALT elevations or hepatotoxicity). 2516891
Eschbach JW, Abdulhadi MH, Browne JK, Delano BG, Downing MR, Egrie JC, Evans RW, et al. Recombinant human erythropoietin in anemic patients with end-stage renal disease. Results of a phase III multicenter clinical trial. Ann Intern Med 1989; 111: 992-1000. (Among 333 anemic patients with ESRD on hemodialysis who were treated with epoetin 3 times weekly, hematocrit levels rose and side effects included hypertension [35%], seizures [5.4%], flu-like symptoms, decrease in ferritin and increase in platelet counts; no mention of ALT elevations or hepatotoxicity). 2688507
Erythropoietin for anemia. Med Lett Drugs Ther 1989; 31 (801): 85-6. (Concise review of the efficacy and safety of epoetin shortly after its US approval for the anemia of chronic renal disease mentions adverse events of hypertension, seizure and clotting of arteriovenous fistulas and shunts; no mention of ALT elevations or hepatotoxicity). 2671624
Nissenson AR. National cooperative rHu erythropoietin study in patients with chronic renal failure: a phase IV multicenter study. Report of National Cooperative rHu Erythropoietin Study Group. Am J Kidney Dis 1991; 18 (4 Suppl 1): 24-33. (In a postmarketing prospective study of 447 patients with chronic renal failure treated with epoetin and followed at 68 centers, average hematocrit levels increased from 25.1% to 30.6% at 3 months and there were “no increases in the incidence of adverse events”). 1928075
Eschbach JW, Egrie JC, Downing MR, Browne JK, Adamson JW. The safety of epoetin-alpha: results of clinical trials in the United States. Contrib Nephrol 1991; 88: 72-80. (Analysis of safety in 493 anemic hemodialysis patients treated with epoetin in 5 clinical trials found the most common side effects were myalgias, fever, local injection reactions; other adverse events were iron deficiency [43%], increase in blood pressure [31%], seizures [4%], and access thromboses; there were “no consistent changes in liver function tests”). 2040198
Obladen M, Maier R, Segerer H, Grauel EL, Holland BM, Stewart G, Jorch G, et al. Efficacy and safety of recombinant human erythropoietin to prevent the anaemias of prematurity. European Randomized Multicenter Trial. Contrib Nephrol 1991; 88: 314-26. (Among 93 preterm newborns treated with recombinant epoetin or placebo subcutaneously every 3 days, there was no difference in need for or amount of red cell transfusion and no differences in adverse events; no mention of ALT or bilirubin elevations). 2040194
Samtleben W, Ehmer B, Lutz-Knochenhauer I, Hagmann C, Scigalla P, Gurland HJ. Side effects during recombinant human erythropoietin therapy in 2,000 ESRD patients. Contrib Nephrol 1991; 88: 107-16. (Among 2138 patients on hemodialysis treated with epoetin, severe complications included convulsions in 28 patients and 14 malignancies, but survival was better than predicted from historical controls; no mention of liver injury, but two patients developed hepatitis B and 2 non-A, non-B hepatitis). 2040172
Henry DH, Beall GN, Benson CA, Carey J, Cone LA, Eron LJ, Fiala M, et al. Recombinant human erythropoietin in the treatment of anemia associated with human immunodeficiency virus (HIV) infection and zidovudine therapy. Overview of four clinical trials. Ann Intern Med 1992; 117: 739-48. (Combined results of 4 controlled trials of epoetin in 297 patients with AIDS found overall increase in hematocrit by 4.6% [vs 0.5% with placebo] and no difference in incidence of adverse events). 1416576
Klinkmann H, Wieczorek L, Scigalla P. Adverse events of subcutaneous recombinant human erythropoietin therapy: results of a controlled multicenter European study. Artif Organs 1993; 17: 219-25. (Among 362 anemic hemodialysis patients in Europe treated with epoetin for 1-2 years, “the observed biochemistry profile shows no significant changes that could be attributed to” epoetin therapy). 8498900
Tanaka H, Kan E, Takegaki Y, Inariba H, Yoshimoto M, Ohno Y, Maekawa M et al. Multicenter study with recombinant human erythropoietin. Artificial Organs 1993; 17: 213-8. (Among 172 Japanese patients with ESRD treated with epoetin for 24 weeks, side effects included increases in blood pressure and heart rate, but not seizures; no mention of ALT elevations or hepatotoxicity). 8498899
Sowade B, Sowade O, Möcks J, Franke W, Warnke H. The safety of treatment with recombinant human erythropoietin in clinical use: a review of controlled studies. Int J Mol Med 1998; 1: 303-14. (Systematic review of published studies of epoetin for rates of adverse events identified side effects that were more frequent with epoetin than placebo in renal anemia, as hypertension [23%], menstrual disorders [9.1% vs 4.1%], injection site reactions [5.7% vs 0], and headache [4.9% vs 2%], among others; liver enzyme increases were no more frequent with epoetin than placebo [5.3% vs 6.5%]). 9852232
Stowell CP, Chandler H, Jové M, Guilfoyle M, Wacholtz MC. An open-label, randomized study to compare the safety and efficacy of perioperative epoetin alfa with preoperative autologous blood donation in total joint arthroplasty. Orthopedics 1999; 22 (1 Suppl): s105-12. (Among 450 patients undergoing joint replacement treated with 4 weekly injections of epoetin or placebo to aid in preoperative blood donation before surgery, side effects were similar between the two groups, although two epoetin treated patients had a stroke and one a myocardial infarction, no mention of ALT elevations or hepatotoxicity). 9927110
Darbepoetin (Aranesp) – a long-acting erythropoietin. Med Lett Drugs Ther 2001; 43 (W2210A): 109-110. (Concise review of the efficacy and safety of darbepoetin a recombinant erythropoietin with 2 additional N-glycosylation sites, which prolongs its half-life allowing once weekly or every other week administration; side effects are similar to those of epoetin; no mention of ALT elevations or hepatotoxicity).
Erythropoietin (Procrit; Epogen) revisited. Med Lett Drugs Ther 2001; 43 (1104): 40-1. (Concise review of the formal indications for epoetin in response to direct patient advertising about its effects on fatigue and ability to work; no mention of adverse events on the liver). 11353925
Vansteenkiste J, Pirker R, Massuti B, Barata F, Font A, Fiegl M, Siena S, et al.; Aranesp 980297 Study Group. Double-blind, placebo-controlled, randomized phase III trial of darbepoetin alfa in lung cancer patients receiving chemotherapy. J Natl Cancer Inst 2002; 94: 1211-20. (Among 320 patients with anemia due to cancer chemotherapy who were treated with weekly injections of darbepoetin or placebo for 12 weeks, adverse events and “changes in laboratory test variables” were similar between the 2 groups; no mention of ALT elevations or hepatotoxicity). 12189224
Hedenus M, Adriansson M, San Miguel J, Kramer MH, Schipperus MR, Juvonen E, Taylor K, et al.; Darbepoetin Alfa 20000161 Study Group. Efficacy and safety of darbepoetin alfa in anaemic patients with lymphoproliferative malignancies: a randomized, double-blind, placebo-controlled study. Br J Haematol 2003; 122: 394-403. (Among 344 patients with lymphoma or myeloma receiving cancer chemotherapy and treated with either darbepoetin or placebo for 12 weeks, adverse events occurred equally in the 2 groups and were considered due to the underlying disease or chemotherapy rather than the interventions; no mention of ALT elevations or hepatotoxicity). 12877666
Farrell F, Lee A. The erythropoietin receptor and its expression in tumor cells and other tissues. Oncologist 2004; 9 Suppl 5: 18-30. (Epoetin and its receptor are found on red cell progenitors, but also in the central nervous system, liver, tumors and the uterus where their function is unknown, but may be involved in cytoprotection and angiogenesis which may be beneficial for some tissue, but may promote cancer cell growth). 15591419
Glaspy J, Vadhan-Raj S, Patel R, Bosserman L, Hu E, Lloyd RE, Boccia RV, et al. Randomized comparison of every-2-week darbepoetin alfa and weekly epoetin alfa for the treatment of chemotherapy-induced anemia: the 20030125 Study Group Trial. J Clin Oncol 2006; 24: 2290-7. (Among 1220 patients with chemotherapy induced anemia treated with darbepoetin weekly or every 2 weeks, adverse events “were consistent with existing clinical experience for adverse events in anemic cancer patients”; no mention of ALT elevations or hepatotoxicity). 16710026
Canon JL, Vansteenkiste J, Bodoky G, Mateos MV, Bastit L, Ferreira I, Rossi G, et al. Randomized, double-blind, active-controlled trial of every-3-week darbepoetin alfa for the treatment of chemotherapy-induced anemia. J Natl Cancer Inst 2006; 98: 273-84. (Among 705 patients with anemia due to cancer chemotherapy treated with darbepoetin given either every week or every 3 weeks, both efficacy and safety were similar with both schedules; hepatic failure was reported in 3 patients, but was considered due to the chemotherapy rather than darbepoetin). 16478746
Shin DH, Kwon YI, Choi SI, Park US, Lee J, Shin JH, Lee JU, et al. Accidental ten times overdose administration of recombinant human erythropoietin (rh-EPO) up to 318,000 units a day in acute myocardial infarction: report of two cases. Basic Clin Pharmacol Toxicol 2006; 98: 222-4. (Two patients with acute myocardial infarction received an incorrect dose of epoetin [318,000 U: 10 times intended] in a clinical trial of cardiac protection and both had an immediate increase in ALT [peak 386 and 98 U/L] that fell to baseline several weeks after; no mention of bilirubin, Alk P or symptoms). 16445599
Arcasoy MO. The non-haematopoietic biological effects of erythropoietin. Br J Haematol 2008; 141: 14-31. (Review of the non-hematologic functions and potential therapeutic uses of epoetin in development, the central nervous system, kidneys, and during inflammation and wound healing; no discussion of liver disease). 18324962
Peginesatide (Omontys) for anemia in chronic kidney failure. Med Lett Drugs Ther 2012; 54 (1392): 45-6. (Concise review of the efficacy and safety of a pegylated synthetic peptide analogue of erythropoietin shortly after its approval for the anemia of chronic renal disease, mentions that its adverse events are similar to those of epoetin; no mention of ALT elevations or hepatotoxicity). 22683926
Macdougall IC. New anemia therapies: translating novel strategies from bench to bedside. Am J Kidney Dis 2012; 59: 444-51. (Overview of erythropoiesis stimulating agents focusing on the long acting forms, including darbepoetin and pegylated epoetin beta and the unique erythropoietin-mimetic dipeptide, peginesatide). 22192713
Schmid H. Peginesatide for the treatment of renal disease-induced anemia. Expert Opin Pharmacother 2013; 14: 937-48. (Review of the structure, mechanism of action, pharmacokinetics, clinical efficacy and safety of peginesatide does not mention ALT elevations or hepatotoxicity). 23506424
Macdougall IC, Provenzano R, Sharma A, Spinowitz BS, Schmidt RJ, Pergola PE, Zabaneh RI, et al.; PEARL Study Groups. Peginesatide for anemia in patients with chronic kidney disease not receiving dialysis. N Engl J Med 2013; 368: 320-32. (Among 983 patients with renal disease and anemia, not on dialysis, who were treated in 2 clinical trials of peginesatide versus darbepoetin for at least 52 weeks, severe adverse events [including sudden death] were more frequent with peginesatide, but an extensive discussion of adverse events included no mention of ALT elevations or hepatotoxicity). 23343062
Fishbane S, Schiller B, Locatelli F, Covic AC, Provenzano R, Wiecek A, Levin NW, et al.; EMERALD Study Groups. Peginesatide in patients with anemia undergoing hemodialysis. N Engl J Med 2013; 368: 307-19. (Among 1418 patients on hemodialysis who were treated in two clinical trials comparing standard regimens of epoetin with peginesatide, rates of severe adverse events were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 23343061
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to epoetin, darbepoetin or other erythropoiesis stimulating agents). 25754159
Park S, Fenaux P, Greenberg P, Mehta B, Callaghan F, Kim C, Tomita D, et al. Efficacy and safety of darbepoetin alpha in patients with myelodysplastic syndromes: a systematic review and meta-analysis. Br J Haematol 2016; 174: 730-47. (Systematic review of the literature on safety of darbepoetin in myelodysplasia, no mention of hepatotoxicity or ALT elevations and no instances of hepatic failure in listings of causes of death). 27214305
Platzbecker U, Symeonidis A, Oliva EN, Goede JS, Delforge M, Mayer J, Slama B, et al. A phase 3 randomized placebo-controlled trial of darbepoetin alfa in patients with anemia and lower-risk myelodysplastic syndromes. Leukemia 2017; 31: 1944-50. (Among 147 patients with myelodysplastic syndromes treated with darbepoetin or placebo once weekly for 48 weeks, there were no hepatic severe adverse events and no mention of ALT elevations or hepatotoxicity). 28626220

## OTHER REFERENCE LINKS

1. Recent References on Erythropoiesis Stimulating Agents: from PubMed.gov (http://s/www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Erythropoiesis%20Stimulating%20Agents+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Erythropoiesis Stimulating Agents: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Erythropoiesis%20Stimulating%20Agents)